# Lubiprostone

## OVERVIEW

### Introduction

Lubiprostone is an activator of chloride channels (ClC-2) in the intestine and is used for treatment of chronic constipation and irritable bowel syndrome. Lubiprostone has not been linked to serum enzyme elevations during treatment or to episodes of clinically apparent liver injury.

### Background

Lubiprostone (loo” bi pros’ tone) is a fatty acid metabolite of prostaglandin E1 that activates the chloride channel protein 2 in the intestine, which increase fluid secretion into the lumen and thus promote intestinal transport. Short term use of lubiprostone increases the number of spontaneous bowel movements and can alleviate symptoms of constipation in patients with chronic idiopathic constipation and irritable bowel syndrome. Lubiprostone was approved for use in the United States in 2006 for short term therapy of chronic idiopathic constipation and indications subsequently expanded to opioid-induced constipation in adults with chronic non-cancer pain and to management of adult women with irritable bowel syndrome and constipation. Lubiprostone is available in capsules of 8 and 24 mcg under the brand name Amitiza. The recommended dose for chronic constipation is 24 mcg twice daily and for irritable bowel syndrome with constipation 8 mcg twice daily. Systemic absorption is minimal, but may be greater in patients with liver disease. Side effects include nausea, diarrhea, abdominal pain and bloating, headache and chest tightness with shortness of breath.

### Hepatotoxicity

In clinical trials, lubiprostone therapy was not associated with significant changes in serum enzyme levels or episodes of clinically apparent liver injury. Since its approval and marketing, isolated case reports of serum aminotransferase elevations have been reported to the sponsor, but there have been no published reports of clinically apparent liver injury attributable to lubiprostone. Thus, liver injury from lubiprostone must be extremely rare, if it occurs at all.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

### Mechanism of Injury

Lubiprostone is largely active on the epithelial cells in the intestinal tract and has minimal absorption. The lack of systemic absorption of lubiprostone and the low daily doses used (in micrograms rather than milligrams) probably account for its lack of causing liver injury.

Drug Class: Gastrointestinal Agents, Drugs for Constipation, Irritable Bowel Syndrome Agents

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Lubiprostone – Amitiza®

DRUG CLASS

Gastrointestinal Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Lubiprostone)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Lubiprostone | 136790-76-6 | C20-H32-F2-O5 | Lubiprostone Chemical Structure

## ANNOTATED BIBLIOGRAPHY

References updated: 25 April 2019

Zimmerman HJ. Laxatives. In, Zimmerman, HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999: pp. 721-3. (Expert review of hepatotoxicity of laxatives published in 1999 before the availability of lubiprostone).
Sharkey KA, MacNaughton WK. Gastrointestinal motility and water flux, emesis; agents used in biliary and pancreatic disease. In, Brunton LL, Hilal-Dandan R, Knollmann BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 921-44. (Textbook of pharmacology and therapeutics; lubiprostone is discussed as an agent for constipation).
Johanson JF, Ueno R. Lubiprostone, a locally acting chloride channel activator, in adult patients with chronic constipation: a double-blind, placebo-controlled, dose-ranging study to evaluate efficacy and safety. Aliment Pharmacol Ther 2007; 25: 1351-61. (Among 129 patients with chronic constipation treated with 3 doses of lubiprostone or placebo for 3 weeks, there was no "clear relationship between the dose of lubiprostone and type or frequency of abnormalities" of blood chemistry results). 17509103
Lubiprostone (Amitiza) for irritable bowel syndrome with constipation. Med Lett Drugs Ther 2008; 50 (1290): 53-4. (Concise review of mechanism of action, safety and efficacy of lubiprostone for irritable bowel syndrome with constipation shortly after its approval for this indication in the United States; side effects include nausea, diarrhea, and chest tightness with difficulty breathing; no mention of ALT elevations or hepatotoxicity). 18617872
Barish CF, Drossman D, Johanson JF, Ueno R. Efficacy and safety of lubiprostone in patients with chronic constipation. Dig Dis Sci 2010; 55: 1090-7. (Among 237 patients with chronic constipation treated with lubiprostone vs placebo, side effects included nausea [24%] and headache [7%], but there were "no clinically relevant changes in laboratory values"). 20012484
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J; Drug Induced Liver Injury Network (DILIN). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology 2008; 135: 1924-34. (Among 300 cases of drug induced liver disease in the US collected between 2004 and 2008, none were attributed to agents used for constipation). 18955056
Ferrajolo C, Capuano A, Verhamme KM, Schuemie M, Rossi F, Stricker BH, Sturkenboom MC. Drug-induced hepatic injury in children: a case/non-case study of suspected adverse drug reactions in VigiBase. Br J Clin Pharmacol 2010; 70: 721-8. (Worldwide pharmacovigilance database contained 9036 hepatic adverse drug reactions in children; there were no gastrointestinal agents in the top 41 causes). 21039766
Reuben A, Koch DG, Lee WM; Acute Liver Failure Study Group. Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology 2010; 52: 2065-76. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury, but none were attributed to gastrointestinal agents, laxatives or drugs for constipation). 20949552
Lembo AJ, Johanson JF, Parkman HP, Rao SS, Miner PB Jr, Ueno R. Long-term safety and effectiveness of lubiprostone, a chloride channel (ClC-2) activator, in patients with chronic idiopathic constipation. Dig Dis Sci 2011; 56: 2639-45. (Among 248 patients with chronic constipation treated with lubiprostone for up to a year, adverse events occurred in 75% of patients, mostly nausea [21%], diarrhea [11%], and headache [10%]; and "there were no clinically meaningful trends" in ALT or AST). 21769655
Chamberlain SM, Rao SS. Safety evaluation of lubiprostone in the treatment of constipation and irritable bowel syndrome. Expert Opin Drug Saf 2012; 11: 841-50. (Review of the safety of lubiprostone based upon data from 522 patients with irritable bowel syndrome; no mention of ALT elevations or hepatotoxicity). 22834474
Shah E, Kim S, Chong K, Lembo A, Pimentel M. Evaluation of harm in the pharmacotherapy of irritable bowel syndrome. Am J Med 2012; 125: 381-93. (Systematic review of adverse side effects of drugs used to treat irritable bowel syndrome, including 3 trials of lubiprostone in which there was no difference in dropout rates due to adverse events between drug and placebo, and the principal side effects seen more often with lubiprostone were nausea and diarrhea). 22444104
Chey WD, Drossman DA, Johanson JF, Scott C, Panas RM, Ueno R. Safety and patient outcomes with lubiprostone for up to 52 weeks in patients with irritable bowel syndrome with constipation. Aliment Pharmacol Ther 2012; 35: 587-99. (Among 520 patients with irritable bowel syndrome treated with lubiprostone for up to 52 weeks, none had a serious adverse event that was attributed to the drug and "Significant changes from baseline...in biochemical laboratory values...were not seen"). 22251419
Hyman PE, Di Lorenzo C, Prestridge LL, Youssef NN, Ueno R. Lubiprostone for the treatment of functional constipation in children. J Pediatr Gastroenterol Nutr 2014; 58: 283-91. (Among 124 children with chronic idiopathic constipation treated with one of 3 doses of lubiprostone, spontaneous bowel movements increased in all groups, adverse events included nausea, diarrhea and abdominal pain and there "were no clinically significant trends in clinical laboratory tests" or serious adverse events judged to be related to lubiprostone therapy). 24048162
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, none were attributed to lubiprostone or other agents used for chronic idiopathic constipation). 25754159
Spierings ELH, Drossman DA, Cryer B, Mazen Jamal M, Losch-Beridon T, Mareya SM, Wang M. Efficacy and safety of lubiprostone in patients with opioid-induced constipation: phase 3 study results and pooled analysis of the effect of concomitant methadone use on clinical outcomes. Pain Med 2018; 19: 1184-94. (Among 451 patients with opioid induced constipation enrolled in a 12 week controlled trial, increases in frequency of spontaneous bowel movements were similar with lubiprostone and placebo therapy, while adverse events rates were minimally higher in the drug-treated group; no mention of ALT elevations or hepatotoxicity). 9016868

## OTHER REFERENCE LINKS

1. Recent References on Lubiprostone: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Lubiprostone+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Lubiprostone: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Lubiprostone)